# Milk Thistle

## OVERVIEW

### Introduction

Milk thistle is an annual or biennial herb native to the Mediterranean region, which has been used for centuries as a food and as a medicinal herb for treatment of liver conditions. Milk thistle has not been implicated in causing liver injury and is still used widely as a liver tonic in patients with acute and chronic liver diseases.

### Background

Milk thistle (Silybum marianum) is an herb native to Europe, Asia Minor and Northern Africa that has been used widely to treat liver disease. Extracts of milk thistle seeds contain multiple flavanolignans, known collectively as silymarin, consisting largely of silybinin, silychristin and silydianin. In cell culture and animal models, silymarin has been shown to prevent or ameliorate acute liver injury due to many toxins including acetaminophen and Amanita phalloides. Human studies of silymarin in patients with chronic liver disease have been promising but inconclusive. Controlled trials of silymarin in chronic hepatitis C and nonalcoholic fatty liver disease found little or no evidence of benefit in ameliorating disease activity or in slowing disease progression. Milk thistle is marketed as capsules or tablets containing ethanol extracted silymarin in amounts of 250 to 750 mg and is purported to be beneficial for liver disease, including alcoholic and viral liver disease. The daily dosage varies but it is typically taken 2 to 3 times daily. Intravenous preparations of purified silybinin are approved in Europe for therapy of Amanita phalloides mushroom poisoning. No prospective controlled trials of intravenous silybinin have been published. Oral silymarin has few if any adverse side effects and is well tolerated even in high daily doses.

### Hepatotoxicity

Despite its wide spread use in patients with and without liver disease, milk thistle has not been implicated in causing serum enzyme elevations or clinically apparent acute liver injury. While silymarin has effects on cytochrome P450 enzymes and hepatic transporters in vitro, there is little evidence that it causes clinically significant herb-drug interactions.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Silybin, Silybum, Silymarin, Marian thistle

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Milk Thistle – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/milkthistle/ataglance.htm)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Milk Thistle | 84604-20-6 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 21 January 2020

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; milk thistle is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] mentions that silymarin is used to treat liver disease but evidence for its benefit is contradictory).
Milk thistle. In, PDR for herbal medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 578-83. (Compilation of short monographs on herbal medications and dietary supplements).
Flora K, Hahn M, Rosen H, Benner K. (1998). Milk thistle (Silybum marianum) for the therapy of liver disease. Am J Gastroenterol. (Review of the evidence of hepatoprotective activities of milk thistle based upon its antioxidants and ability to scavenge free radicals and inhibit lipid peroxidation, but evidence in human trials has been inconclusive; intravenous silymarin protects laboratory animals exposed to Amanita phalloides and open label studies in humans have reported higher than expected survival rates).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions; milk thistle is not discussed).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity; milk thistle is not listed as causing hepatotoxicity).
Gordon A, Hobbs DA, Bowden DS, Bailey MJ, Mitchell J, Francis AJ, Roberts SK. (2006). Effects of Silybum marianum on serum hepatitis C virus RNA, alanine aminotransferase levels and well-being in patients with chronic hepatitis C. J Gastroenterol Hepatol. (17 patients with chronic hepatitis were treated for 12 weeks with silymarin or placebo in a cross over study; there were no significant changes in HCV RNA or ALT levels and adverse events were similar in the two groups).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none attributed to milk thistle).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by “natural remedies”: an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. PMID: 19159172 (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none attributed to milk thistle).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, milk thistle is not listed).
Ferenci P, Scherzer TM, Kerschner H, Rutter K, Beinhardt S, Hofer H, Schöniger-Hekele M, et al. (2008). Silibinin is a potent antiviral agent in patients with chronic hepatitis C not responding to pegylated interferon/ribavirin therapy. Gastroenterology. (Intravenous infusion of silibinin daily for 7 days led to rapid and marked fall in serum HCV RNA levels in 30 patients with chronic hepatitis C, the decrease starting within one day, ranging from 1 to 5 log[10] IU/mL, being dose dependent and usually followed by a rise once infusions were stopped).
Rambaldi A, Jacobs BP, Gluud C. (2007). Milk thistle for alcoholic and/or hepatitis B or C virus liver diseases. Cochrane Database Syst Rev. (Systematic review concluded that milk thistle had no significant effects on mortality in patients with alcoholic liver disease or chronic hepatitis B or C and was not associated with an increased risk of adverse events).
El-Kamary SS, Shardell MD, Abdel-Hamid M, Ismail S, El-Ateek M, Metwally M, Mikhail N, et al. (2009). A randomized controlled trial to assess the safety and efficacy of silymarin on symptoms, signs and biomarkers of acute hepatitis. Phytomedicine. (Controlled trial of 4 week course of silymarin vs placebo in 105 patients with acute viral hepatitis found no differences in outcome, but minimally faster resolution of dark urine and jaundice; there were no serious adverse events and side effects were uncommon and similar in frequency between the two groups).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; milk thistle is not listed as a potentially hepatotoxic botanical).
Abenavoli L, Capasso R, Milic N, Capasso F. (2010). Milk thistle in liver diseases: past, present, future. Phytother Res. (Review of the history, active components, mechanism of action, in vitro and in vivo studies of activity and clinical efficacy and safety of milk thistle; the active component is found in lipophilic extracts of the plant seeds and is composed of flavonolignands, silybin, silydianin and silychristin, collectively known as silymarin, which acts as an antioxidant, antifibrotic and toxin blockading agent).
Wagoner J, Negash A, Kane OJ, Martinez LE, Nahmias Y, Bourne N, Owen DM, et al. (2010). Multiple effects of silymarin on the hepatitis C virus lifecycle. Hepatology. (Silymarin inhibited hepatitis C virus replication in cell culture systems, inhibiting virus entry, viral RNA and protein production and production of infectious virus).
Ladas EJ, Kroll DJ, Oberlies NH, Cheng B, Ndao DH, Rheingold SR, Kelly KM. (2010). A randomized, controlled, double-blind, pilot study of milk thistle for the treatment of hepatotoxicity in childhood acute lymphoblastic leukemia (ALL). Cancer. (Among 50 children receiving induction chemotherapy for acute leukemia who were treated with milk thistle [5 mg/kg] or placebo by mouth daily for 28 days, there were no differences in mean changes in ALT, AST, or serum bilirubin, although there was “a trend” for lower levels of liver toxicity with silymarin).
Payer BA, Reiberger T, Rutter K, Beinhardt S, Staettermayer AF, Peck-Radosavljevic M, Ferenci P. (2010). Successful HCV eradication and inhibition of HIV replication by intravenous silibinin in an HIV-HCV coinfected patient. J Clin Virol. (27 year old woman with chronic hepatitis C and HIV infection was treated with two weeks of daily intravenous silibinin overlapping by one week with 16 weeks of peginterferon and ribavirin, and had a sustained HCV and transient HIV virological response).
Schrieber SJ, Hawke RL, Wen Z, Smith PC, Reddy KR, Wahed AS, Belle SH, et al. (2011). Differences in the disposition of silymarin between patients with nonalcoholic fatty liver disease and chronic hepatitis C. Drug Metab Dispos. Pharmacokinetic and safety study of escalating doses of silymarin in 18 patients with hepatitis C and 12 with nonalcoholic fatty liver found no evidence of toxicity when given in high doses of up to 8 days).
Loguercio C, Festi D. (2011). Silybin and the liver: from basic research to clinical practice. World J Gastroenterol. (Review of the chemical structure, mechanisms of action, and clinical efficacy of silybin, a component of milk thistle; no discussion of safety and no mention of hepatotoxicity).
Choi YH, Chin YW, Kim YG. (2011). Herb-drug interactions: focus on metabolic enzymes and transporters. Arch Pharm Res. (Summary and review of in vitro and clinical evidence of herb-drug interactions).
Fried MW, Navarro VJ, Afdhal N, Belle SH, Wahed AS, Hawke RL, Doo E, et al. (2012). Silymarin in NASH and C Hepatitis (SyNCH) Study Group. Effect of silymarin (milk thistle) on liver disease in patients with chronic hepatitis C unsuccessfully treated with interferon therapy: a randomized controlled trial. JAMA. (Controlled trial of 6 month course of two doses of silymarin vs placebo in 154 patients with chronic hepatitis C found no effect on ALT or HCV RNA levels, and side effects were similar in the silymarin and placebo treated groups).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which were attributed to a herbal or dietary product, but none specifically to milk thistle).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to milk thistle or other herbal products).
Gores KM, Hamieh TS, Schmidt GA. (2014). Survival following investigational treatment of amanita mushroom poisoning: thistle or shamrock?. Chest. (71 year old man developed acute liver failure 2 days after consuming wild mushrooms [bilirubin 1.5 mg/dL, ALT 2730 U/L, INR 1.3] and was treated experimentally with intravenous silymarin [but only after 4 days when laboratory results were already improving] and recovered rapidly).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 145 [16%] were attributed to herbal and dietary supplements, but none specifically to milk thistle).
Zhang S, Pan H, Peng X, Lu H, Fan H, Zheng X, Xu G, Wang M, Wang J. (2016). Preventive use of a hepatoprotectant against anti-tuberculosis drug-induced liver injury: A randomized controlled trial. J Gastroenterol Hepatol. (Among 379 adults being treated for tuberculosis who were given S. marianum or vitamin C as a hepatoprotectant, clinically apparent liver injury occurred in 1 of the silymarin- but none of the vitamin C-treated controls, and rates of ALT elevations were somewhat higher with silymarin [44% vs 36%]).
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. (2016). Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci. (Listing of names of herbal and dietary supplements implicated in published cases of liver injury does not list or mention silymarin or milk thistle).
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. 2017;107(Pt A):472–501. PMID: 27402097 (In a comprehensive online compendium of names of herbal and dietary supplements implicated in cases of liver toxicity, milk thistle is not listed).
Abenavoli L, Izzo AA, Milić N, Cicala C, Santini A, Capasso R. (2018). Milk thistle (Silybum marianum): A concise overview on its chemistry, pharmacological, and nutraceutical uses in liver diseases. Phytother Res. (Review of the chemistry, pharmacology, clinical efficacy and safety of milk thistle concludes that despite the antiinflammatory, antioxidant and antifibrotic properties observed in animal studies of milk thistle, its efficacy in patients with liver disease “is not fully compelling”).
Navarro VJ, Belle SH, D'Amato M, Adfhal N, Brunt EM, Fried MW, Reddy KR, et al. (2019). Silymarin in NASH and C Hepatitis (SyNCH) Study Group. Silymarin in non-cirrhotics with non-alcoholic steatohepatitis: A randomized, double-blind, placebo-controlled trial. PLoS One. (Among 78 adults with nonalcoholic fatty liver disease treated with silymarin [420 or 700 mg] or placebo 3 times daily for 48 weeks, there were no differences in ALT or AST levels or liver histological changes among the 3 treatment groups and no differences in adverse event rates despite the high levels of silymarin used).
Soleimani V, Delghandi PS, Moallem SA, Karimi G. (2019). Safety and toxicity of silymarin, the major constituent of milk thistle extract: An updated review. Phytother Res. (Review of the safety of silymarin mentions that it was found to have no toxicity in animals and to be safe in humans even when used in high doses [2.1 gm daily] or in patients with liver disease, the usual reported adverse events being mild and transient nausea and diarrhea).

## OTHER REFERENCE LINKS

1 Recent References on Milk Thistle: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Milk+Thistle+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Milk Thistle: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Milk+Thistle)